# Fezolinetant

## OVERVIEW

### Introduction

Fezolinetant is an orally available neurokinin 3 receptor antagonist that is used to treat women with vasomotor symptoms (such as hot flashes) due to menopause. Fezolinetant is associated with a low rate of serum aminotransferase elevations during therapy and has been linked to rare instances of clinically apparent liver injury with jaundice.

### Background

Fezolinetant (fez oh’ lin eh tant) is a neurokinin 3 (NK3) receptor antagonist that is used to treat moderate-to-severe vasomotor symptoms due to menopause. The neurokinin 3 receptor is found on neurons in the thermoregulatory center of the brain, is activated by binding to neurokinin B, and is inhibited by circulating estrogen levels. During menopause, estrogen levels fall, and neurokinin B binding is unopposed, which leads to altered thermoregulation manifested by hot flashes, episodes of sensations of heat in the upper body lasting 1 to 5 minutes arising multiple times per day and which can be accompanied by flushing, chills, perspiration, clamminess and anxiety, symptoms that can interfere with activities of daily living and quality of life. Conventional therapy of menopausal vasomotor symptoms is estrogen replacement, which is effective but can be associated with adverse events including an increased risk of hormone-sensitive cancers. Fezolinetant is a small molecule, nonhormonal inhibitor of neurokinin binding and has been shown to decrease both the frequency and the severity of the vasomotor symptoms. Fezolinetant was approved for use in the United States in 2019 and is available in tablets of 45 mg under the brand name Veozah. The recommended dose is 45 mg daily. Current indications are for moderate-to-severe vasomotor symptoms due to menopause. Contraindications include cirrhosis, end-stage renal disease, and concurrent therapy with inhibitors of CYP 1A2, the cytochrome P450 enzyme primarily responsible for its metabolism. Fezolinetant is generally well tolerated. Side effects can include serum aminotransferase elevations, abdominal pain, diarrhea, insomnia, and back pain.

### Hepatotoxicity

In preregistration clinical trials, serum ALT or AST elevations above 3 times the upper limit of normal (ULN) occurred in 2.3% of patients taking fezolinetant vs 0.9% of placebo recipients. The elevations were largely asymptomatic and transient, resolving promptly after stopping therapy and sometimes despite drug continuation. Nevertheless, the elevations appeared to be related to therapy and arose most frequently during the first few months of treatment. More striking elevations arose in early phase trials using higher doses of fezolinetant. Bilirubin elevations were rare and there were no instances of clinically apparent liver injury with jaundice in preregistration clinical studies even with high doses. However, within a year of its approval, a case of mixed-cholestatic hepatitis with symptoms and jaundice occurred in a patient taking fezolinetant. The episode arose within 54 days of starting fezolinetant and resolved once the drug was stopped. Because of this case, the warning about drug induced liver injury was strengthened, and more explicit recommendations were made regarding prescreening and monitoring patients in the product label of fezolinetant.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism by which fezolinetant might cause liver injury is unclear, but it may be dose related and direct hepatotoxicity. Fezolinetant is metabolized in the liver primarily by CYP 1A2 and inhibitors of this isoenzyme (such as cimetidine and ciprofloxacin) can result in higher drug levels and possibly increased rate of adverse events.

### Outcome and Management

The product label for fezolinetant has a warning about drug induced liver injury and recommends assessing symptoms and laboratory features of liver disease before starting therapy and monitoring routine liver tests thereafter monthly for 3 months, again at 6 and 9 months, thereafter if signs of symptoms of liver injury arise. Fezolinetant should be discontinued if ALT or AST levels rise to above 5 times ULN or above 3 times ULN if symptoms or jaundice are present. Patients found to have serum aminotransferase elevations should be followed more carefully until they resolve. Fezolinetant is contraindicated in women with cirrhosis or renal failure and should be used with caution in those with liver test abnormalities at baseline.

Drug Class: Obstetrical and Gynecological Agents

Other Menopausal Symptom Agents: Estrogens

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fezolinetant – Veozah®

DRUG CLASS

Obstetrical and Gynecological Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fezolinetant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fezolinetant | 1629229-37-3 | C16-H15-FN6-OS

## ANNOTATED BIBLIOGRAPHY

References updated: 10 October 2024

Abbreviations: NK3, neurokinin 3.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of NK3 receptor antagonists).
FDA. Clinical Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216578Orig1s000MedR.pdf (FDA website with product label and integrated clinical review of data on fezolinetant provided by the sponsor in support of its approval as therapy of the vasomotor symptoms of menopause, mentions that in a pooled analysis of 3 randomized, placebo controlled trials, serum aminotransferase elevations above 3 times the upper limit of normal [ULN] occurred in 2.3% of fezolinetant- [n=1100] vs 0.9% of placebo-recipients [n=952], but that no patient developed liver injury with jaundice, and the abnormalities resolved with dose interruption or discontinuation. Nevertheless, the FDA recommended a warning about drug induced liver injury and monitoring of liver tests during therapy).
Depypere H, Timmerman D, Donders G, Sieprath P, Ramael S, Combalbert J, Hoveyda HR, et al. Treatment of menopausal vasomotor symptoms with fezolinetant, a neurokinin 3 receptor antagonist: a phase 2a trial. J Clin Endocrinol Metab. 2019;104:5893-5905. (Among 87 women with vasomotor symptoms due to menopause treated with fezolinetant [90 mg] or placebo twice daily for 12 weeks, the frequency and severity of vasomotor symptoms decreased with fezolinetant treatment within 1-2 weeks and relapsed at a similar rate upon stopping, while adverse event rates were similar in the two groups except for gastrointestinal complaints [14% vs none] and ALT elevations [11% vs 2%], all of the latter being transient, less than 3 times ULN, and not requiring dose adjustment or discontinuation). 31415087
Fraser GL, Lederman S, Waldbaum A, Kroll R, Santoro N, Lee M, Skillern L, et al. A phase 2b, randomized, placebo-controlled, double-blind, dose-ranging study of the neurokinin 3 receptor antagonist fezolinetant for vasomotor symptoms associated with menopause. Menopause. 2020;27:382-392. (Among 352 women with moderate-to-severe vasomotor symptoms due to menopause treated with varying doses of fezolinetant [15 to 90 mg twice daily or 30 to 120 mg once daily] or placebo for 12 weeks, vasomotor symptoms were reduced in frequency and severity with all regimens compared to placebo, and total adverse event rates were similar, but ALT or AST elevations arose in 9 [3%] patients on fezolinetant and were above 8 times ULN in 3 who were receiving 60 mg or more daily; all abnormalities resolved once drug was stopped and there were no ALT elevations accompanied by jaundice). 32102086
Fraser GL, Obermayer-Pietsch B, Laven J, Griesinger G, Pintiaux A, Timmerman D, Fauser BCJM, et al. Randomized controlled trial of neurokinin 3 receptor antagonist fezolinetant for treatment of polycystic ovary syndrome. J Clin Endocrinol Metab. 2021;106:e3519-e3532. (Among 73 women with polycystic ovary syndrome treated with fezolinetant [60 or 180 mg] or placebo once daily for 12 weeks, FSH and LH levels were suppressed in a dose-dependent manner with fezolinetant and therapy was well tolerated, there were “no clinically relevant changes in clinical laboratory parameters” and “treatment-emergent ALT increases…were equally distributed over the treatment groups”, only one fezolinetant treated patient had an ALT elevation above 3 times ULN and it resolved spontaneously without dose adjustment). 34000049
Neal-Perry G, Cano A, Lederman S, Nappi RE, Santoro N, Wolfman W, English M, et al. Safety of fezolinetant for vasomotor symptoms associated with menopause: a randomized controlled trial. Obstet Gynecol. 2023;141:737-747. (Among 1830 women with vasomotor symptoms due to menopause treated with fezolinetant [30 or 45 mg] or placebo once daily for 52 weeks, total and severe adverse event rates were similar in the 3 groups as were discontinuations for adverse events; ALT and AST elevations of greater than 3 times ULN were uncommon [1.4% and 2.0% vs 1.0%], and no patient developed clinically apparent liver injury with jaundice). 36897180
Lederman S, Ottery FD, Cano A, Santoro N, Shapiro M, Stute P, Thurston RC, et al. Fezolinetant for treatment of moderate-to-severe vasomotor symptoms associated with menopause (SKYLIGHT 1): a phase 3 randomised controlled study. Lancet. 2023;401:1091-1102. (Among 527 women with moderate-to-severe vasomotor symptoms due to menopause treated with fezolinetant [30 or 45 mg] or placebo once daily for 12 weeks, followed by an extension study in which all received fezolinetant, improvements in frequency and severity of vasomotor symptoms were greater with fezolinetant, arising within 1 week of starting and maintained for 52 weeks, while adverse events were similar in the 3 groups, ALT elevations during the 12 week period arose in 4 [2.3%] patients on placebo and 4 [1.1%] on fezolinetant, which were above 3 times ULN in 0.6% of both groups). 36924778
Fezolinetant (Veozah) for menopausal vasomotor symptoms. Med Lett Drugs Ther. 2023;65:97-99. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of fezolinetant, mentions that therapy can cause serum aminotransferase elevations and patients should be monitored for liver function and injury tests at baseline and at regular times thereafter). 37339088
Johnson KA, Martin N, Nappi RE, Neal-Perry G, Shapiro M, Stute P, Thurston RC, et al. Efficacy and safety of fezolinetant in moderate to severe vasomotor symptoms associated with menopause: a phase 3 RCT. J Clin Endocrinol Metab. 2023;108:1981-1997. (Among 501 women with moderate-to-severe vasomotor symptoms due to menopause treated with fezolinetant [30 or 45 mg] or placebo once daily for 12 weeks and then continued on either 30 or 45 mg of fezolinetant, treatment led to a rapid decrease in frequency and severity of vasomotor symptoms which was maintained during extended therapy, and ALT elevations above 3 times ULN arose in 5 [1.5%] on fezolinetant and 1 [0.6%] on placebo, but all abnormalities resolved and there were no instances of clinically apparent liver injury with jaundice). 36734148
Lee A. Fezolinetant: first approval. Drugs. 2023;83:1137-1141. (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of fezolinetant shortly after its approval in the US, mentions that total and serious adverse event rates were similar in fezolinetant- and placebo-treated subjects and that adverse events more frequent with fezolinetant included abdominal pain [4.3% vs 2.1%], diarrhea [3.9% vs 2.6%], insomnia [3.9% vs 1.8%], back pain [3.0% vs 2.1%], hot flush [2.5% vs 1.6%], and serum aminotransferase elevations [2.3% vs 0.8%]). 37462862
Drugs for menopausal symptoms. Med Lett Drugs Ther. 2024;66:33-38. (Concise review of drugs that are approved for therapy of genitourinary and vasomotor symptoms related to menopause, briefly discusses fezolinetant, a nonhormonal therapy for vasomotor symptoms, which can cause adverse events such as abdominal pain, diarrhea, insomnia, back pain, and hepatic aminotransferase elevations). 38412276
Rani P, Zehra D, Mansoor M, Rani P. FDA approved fezolinetant (Veozah): a critical evaluation of its efficacy and safety for menopausal vasomotor symptoms, calling for prospective research. Arch Womens Ment Health. 2024. Epub ahead of print. (Short review of the data on efficacy and safety of fezolinetant that supported the FDA decision for its approval as therapy of women with moderate-to-severe vasomotor symptoms due to menopause, mentions that serum aminotransferase elevations arose in a small proportion of treated patients [2.3%] but there were no cases of liver injury with jaundice). 38478035

## OTHER REFERENCE LINKS

1. Recent References on Fezolinetant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fezolinetant/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Fezolinetant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fezolinetant)